# Anthelmintic Agents

## OVERVIEW

Helminths consist of a diverse group of parasitic worms including nematodes (round worms), trematodes (flat worms) and cestodes (tapeworms). These infect a significant proportion of people living in resource poor regions. The pathophysiology of disease varies depending on the species and the worm burden. Infections caused by Strongyloides stercoralis, Toxocara sp. and Enterobius vermicularis (pinworms) are endemic in the United States but rarely cause clinically significant disease. Other enzootic infections are uncommonly encountered in the United States. Worldwide, helminth infections of the gastrointestinal tract are most common (pinworms, hookworms, Ascaris, Trichuris). Other nematodes have blood (Filaria sp.), skin (Onchocerca) or muscle stages (Trichinella sp.). Schistosomes, which reside in the blood stream, are the most common trematode (fluke) infection worldwide. Other trematodes infect the gastrointestinal or biliary tract (many species) or lungs (Paragonimus sp.). Tapeworms consist of two stages that infect humans. The adult tapeworm stage resides in the intestine, but the form that causes disease is the larval stage. Thus, larval cysts of Taenia solium are found in the brain and cysts of Echinococcus in the liver or lung.

Anthelmintics, sometimes spelled antihelminthics, are a variety of agents and chemical compounds used for a great variety of parasitic infections. Anthelmintic agents available in the United States [with year of approval] include the benzimidazoles (thiabendazole [1967], mebendazole [1974], albendazole [1996], and triclabendazole [2019]), ivermectin [1996], nitazoxanide [2004], praziquantel [1982], pyrantel pamoate and niclosamide [not available in the United States]. Their mechanisms of action vary, but they frequently cause paralysis of the parasitic worm leading to its release and expulsion. With some exceptions, agents are specific to the category of parasite. As examples, praziquantel is employed in the treatment of trematodes and ivermectin for nematodes. Albendazole is broadly effective for many nematodes and some trematodes and protozoa. Triclabendazole is the drug of choice for chronic fascioliasis and has been used for decades in much of the world but was approved for use in the United States (where Fasciola infection is rare) only in 2019. Importantly, the dose and duration of anthelmintic therapy varies considerably based upon the indication. For gastrointestinal infestations, a single dose of a poorly absorbed anthelmintic is usually effective, but dosing may have to be repeated once or twice or given for 1 to 3 days particularly for trichuriasis. For systemic infections, multiple or a more prolonged course may be necessary, which can vary from 1 or 2 doses to daily doses for several months or years. Uncommonly, continuous therapy is needed for suppression.

Anthelmintics associated with hepatotoxicity include the benzimidazoles such as thiabendazole (now withdrawn), mebendazole and albendazole which have been linked to rare instances of hepatocellular or mixed liver injury, but which can be severe and prolonged. The other anthelmintics appear to have little hepatotoxic potential. In most instances, these agents are given for a short period only and many are not absorbed to a major extent.

With one exception, only the major anthelmintics approved and available in the United States are discussed in this website. The exception is fenbendazole, a benzimidazole that is approved in the United States only as a veterinary drug for parasitic worm infestations in livestock and in domestic cats and dogs. Fenbendazole has been claimed to have antineoplastic activity in vitro and is promoted by social media on the internet as an alternative therapy for cancer. Several instances of benzimidazole liver injury have been reported in patients taking fenbendazole on their own to treat advanced or metastatic cancer, often in combination with conventional antineoplastic agents.

The following anthelmintic agents are discussed individually in LiverTox:

• Albendazole

• Ivermectin

• Fenbendazole

• Mebendazole

• Nitazoxanide

• Pentamidine

• Praziquantel

• Pyrantel

• Thiabendazole

• Triclabendazole